# Rilpivirine

## OVERVIEW

### Introduction

Rilpivirine is a nonnucleoside reverse transcriptase inhibitor used in combination with other antiretroviral agents in the therapy of human immunodeficiency virus (HIV) infection. Rilpivirine is associated with a low rate of transient serum aminotransferase elevations during therapy and has been implicated in rare cases of clinically apparent acute liver injury.

### Background

Rilpivirine (ril" pi vir' een) is an antiretroviral agent that acts by noncompetitive binding to, and inhibition of the HIV reverse transcriptase. Rilpivirine is a nonnucleoside reverse transcriptase inhibitor similar in action to nevirapine, efavirenz, delavirdine and etavirine. In several randomized controlled trials, rilpivirine was found to have similar efficacy to efavirenz when combined with at least two nucleoside analogues (typically tenofovir and emtricitabine). Rilpivirine was the fifth nonnucleoside reverse transcriptase inhibitor approved by the FDA [2011], and current indications are for the treatment of HIV infection in combination with other HIV medications. Rilpivirine is available under the brand name Edurant in tablets of 25 mg. The recommended dose is 25 mg orally once daily with a meal. Rilpivirine is also available in a fixed dose combination (25 mg) once a day tablet with emtricitabine (200 mg) and tenofovir disoproxil fumarate (300 mg) under the brand name Complera [2011] and a similar combination with tenofovir alafenamide fumarate (25 mg) under the brand name Odefsey [2016]. Antiviral resistance can occur and resistance patterns are similar to, and cross react with those due to other nonnucleoside reverse transcription inhibitors. Common side effects include fatigue, dizziness, headache, insomnia, depression and skin rashes.

### Hepatotoxicity

Serum aminotransferase elevations occur in 25% or more of patients on rilpivirine therapy, but elevations above 5 times the upper limit of normal are uncommon, occurring in 1% to 4% of patients. The rate of serum aminotransferase elevations during rilpivirine therapy is higher in patients who are coinfected with hepatitis B or C [~10% have values greater than 5 times ULN]. The product label for rilpivirine induces a warning about hepatotoxicity particularly in patients with HBV or HCV coinfection and recommends monitoring for liver test abnormalities. During the first several years of wide spread clinical use of rilpivirine, a single case report of liver injury was published. The case was marked by prominent elevations in serum ALT and AST without jaundice arising within days of starting therapy and resolving rapidly upon stopping (Case 1). There was no rash, eosinophilia or other prominent immunoallergic features which are typical of the liver injury associated with nevirapine and efavirenz. Thus, clinically apparent hepatotoxicity due to rilpivirine may occur but is rare.

Liklihood score: D (possible rare cause of clinically apparent liver injury).

### Mechanism of Injury

While hepatotoxicity from rilpivirine may be rare, it is likely due to hypersensitivity. Rilpivirine is extensively metabolized in the liver via the cytochrome P450 system (predominantly CYP 3A4) and production of a toxic or immunogenic intermediate may trigger liver injury.

### Outcome and Management

The severity of the liver injury linked to rilpivirine therapy has been mild and self-limited and characterized by serum aminotransferase elevations with no or minimal symptoms and no rash. Recovery has been prompt upon drug discontinuation. Rilpivirine has not been linked to cases of acute liver failure, chronic hepatitis or vanishing bile duct syndrome. There is no information on cross sensitivity to hepatic injury between rilpivirine and other nonnucleoside reverse transcriptase inhibitors, although there may be cross reactivity in occurrence of rash.

Drug Class: Antiviral Agents, Antiretroviral Agents

Other Drugs in the Subclass, Nonnucleoside Reverse Transcriptase Inhibitors: Delavirdine, Doravirine, Efavirenz, Etravirine, Nevirapine

## CASE REPORT

### Case 1. Mild hepatitis arising within a few days of starting rilpivirine.

[Modified from: Ahmed Y, Siddiqui W, Enoch CB, Albrecht H, Bookstaver PB. Rare case of rilpivirine-induced severe allergic hepatitis. J Antimicrob Chemother 2012 Oct 12. [Epub ahead of print] PubMed Citation (https://www.ncbi.nlm.nih.gov/pubmed/23065700)]

A 28 year old man with HIV and mycobacterium avium intracellulare complex (MAC) infection on long term antiretroviral therapy developed fatigue, nausea and fever within days of changing his antiviral regimen to include rilpivirine. He had a long history of HIV infection for which he had received various antiretroviral regimens that most recently had included tenofovir, emtricitabine, raltegravir and zidovudine. To simplify his regimen, he was switched to a once daily combination of rilpivirine, tenofovir and emtricitabine. His other medications included azithromycin and ethambutol for MAC infection, atovaquone for Pneumocystis jiroveci prophylaxis, and amlodipine and carvedilol for hypertension, all of which he had taken for more than a year. Within a few days of starting the new regimen, he developed progressive weakness, fatigue, nausea and fever. He had no recent exposures to viral hepatitis and had had normal routine liver tests in the past. He denied excessive alcohol intake. On examination, he was febrile (39.2 ^o^C) and had tachycardia (102 beats/min), but was not jaundiced and had no rash or signs of chronic liver disease. Laboratory testing showed marked elevations in serum aminotransferase levels (ALT 1516 U/L, AST 5931) with mild increases in alkaline phosphatase (239 U/L), normal bilirubin (1.0 mg/dL), mild renal impairment (creatinine 2.5 mg/dL), and no eosinophils (Table). Tests for hepatitis A, B and C were negative as were blood alcohol and acetaminophen levels and a urine toxicology screen. All medications were stopped and he received supportive care and hydration. His liver test abnormalities improved rapidly and were almost normal by hospital day 16. His medications were then restarted, but the antiretroviral regimen was changed to tenofovir, emtricitabine, atazanavir, low dose ritonavir and raltegravir without rilpivirine. In follow up, his liver enzymes were normal.

#### Key Points

Medication: | Rilpivirine (25 mg daily)
Pattern: | Hepatocellular (R=9.1)
Severity: | 1+ (no jaundice)
Latency: | 4 days
Recovery: | Complete in 4 weeks
Other medications: | Tenofovir, emtricitabine, atovaquone, ethambutol, azithromycin, carvedilol and amlodipine (all were later restarted without recurrence)

#### Laboratory Values

Time After Starting | Days After Stopping | ALT (U/L) | Alk P (U/L) | Bilirubin (mg/dL) | Other
Pre | Pre | 20 | - | -
4 days | 0 | 1516 | 293 | 1.0 | Admission
6 days | 2 days | 775 | 110
8 days | 4 days | 614 | 195
13 days | 9 days | 170 | 178
19 days | 15 days | 107 | 157 | | Drugs restarted
5 weeks | 1 month | 24 | 134 | | Outpatient clinic
Normal Values | | <78 | <136 | <1.2

#### Comment

A young man with HIV infection and MAC infection developed fever, fatigue and marked serum aminotransferase elevations within 4 days of starting rilpivirine. He was taking several other medications with a potential for hepatotoxicity, but rilpivirine was the only agent that was recently started. The mode of onset and clinical course resembled acute hepatic necrosis with sudden marked increases in ALT and AST, but minimal or no increase in alkaline phosphatase and bilirubin followed by a rapid decline upon stopping the drug. The INR and either LDH or CPK levels would have been helpful, but were not reported. The differential diagnosis for this clinical pattern includes acetaminophen overdose and acute cocaine toxicity, but toxicology screening ruled out these possibilities. Another possible diagnosis was shock, hypoxia or ischemia, but the history did not suggest such an episode (although the patient was clearly dehydrated upon presentation). The published case was described as "severe", but without jaundice or coagulation abnormalities it is more accurate to describe the case as mild or at most moderate in severity. Furthermore, the hepatitis was described as "allergic", but besides fever there were no other allergic features such as rash, facial edema, lymphadenopathy, lymphocytosis or eosinophilia. Immunoallergic hepatitis is typical of the hepatotoxicity of nevirapine and efavirenz, two first generation nonnucleoside reverse transcriptase inhibitors.

## PRODUCT INFORMATION

REPRESENTATIVE TRADE NAMES

Rilpivirine – Edurant®

Rilpivirine, Emtricitabine, Tenofovir – Complera®

DRUG CLASS

Antiviral Agents

COMPLETE LABELING (https://dailymed.nlm.nih.gov/dailymed/search.cfm?labeltype=all&query=rilpivirine)

Product labeling at DailyMed, National Library of Medicine, NIH

## CHEMICAL FORMULA AND STRUCTURE

DRUG | CAS REGISTRY NUMBER | MOLECULAR FORMULA | STRUCTURE
Rilpivirine | 500287-72-9 | C22-H18-N6 | Rilpivirine Chemical Structure

## ANNOTATED BIBLIOGRAPHY

References updated: 20 February 2017

Núñez M. Hepatic toxicity of antiviral agents. In, Kaplowitz N, DeLeve LD, eds. Drug-induced liver disease. 3rd ed. Amsterdam: Elsevier, 2013, pp. 505-18. (Review of hepatotoxicity of antiviral agents without specifically mentioning rilpivirine).
Flexner C. Antiretroviral agents and treatment of HIV infection. In, Brunton LL, Chabner BA, Knollman BC, eds. Goodman & Gilman’s the pharmacological basis of therapeutics. 12th ed. New York: McGraw-Hill, 2011, pp. 1623-64. (Textbook of pharmacology and therapeutics).
http://aidsinfo.nih.gov/guidelines. (Clinical guidelines on the use of antiretroviral agents in HIV-1 infected adults, adolescents and children).
Sulkowski MS, Thomas DL, Chaisson RE, Moore RD. Hepatotoxicity associated with antiretroviral therapy in adults infected with human immunodeficiency virus and the role of hepatitis C or B virus infection. JAMA 2000; 283: 74-80. (Among 298 patients with HIV infection, ALT elevations above 5 times ULN occurred in 10.4% per year during antiretroviral treatment; factors associated with ALT elevations included ritonavir [27.3%] and coinfection with either HCV or HBV; ALT with bilirubin elevations occurred in 3 patients; 2 on indinavir and all 3 with coinfection). 10632283
Dieterich DT, Robinson PA, Love J, Stern JO. Drug-induced liver injury associated with the use of nonnucleoside reverse-transcriptase inhibitors. Clin Infect Dis 2004; 38 Suppl 2: S80-9. (Review of hepatotoxicity of nonnucleoside reverse transcriptase inhibitors; rate of ALT elevations >5 times ULN is ~6% at 6 weeks, but thereafter is similar in nevirapine and placebo recipients, raising questions regarding the causality of late elevations; in meta analysis of 21 studies, ALT elevations >5 times normal occurred in 10.8% on efavirenz, 8.9% on nevirapine and only 3.6% on delaviridine; about half of elevations associated with symptoms). 14986279
Torti C, Lapadula G, Casari S, Puoti M, Nelson M, Quiros-Roldan E, Bella D, et al.; EPOKA-MASTER Study Group. Incidence and risk factors for liver enzyme elevation during highly active antiretroviral therapy in HIV-HCV co-infected patients: results from the Italian EPOKA-MASTER Cohort. BMC Infect Dis 2005; 5: 58. (Among 1038 HIV-HCV coinfected patients starting antiretroviral therapy, the risk of ALT elevations above 5 times ULN was 17.1% yearly in treatment naï and 8.2% in treatment experienced patients; risk factors being baseline ALT levels and use of nonnucleoside reverse transcriptase inhibitors). 16018804
Labarga P, Soriano V, Vispo ME, Pinilla J, Martin-Carbonero L, Castellares C, Casado R, et al. Hepatotoxicity of antiretroviral drugs is reduced after successful treatment of chronic hepatitis C in HIV-infected patients. J Infect Dis 2007; 196: 670-6. (Among 133 patients with HIV-HCV coinfection who were treated with interferon or peg interferon, 33% had a sustained response and subsequent yearly rate of hepatic events was higher among nonresponders [12.9%] than responders [3.1%]; also more common with receipt of di-deoxynucleosides). 17674307
Jain MK. Drug-induced liver injury associated with HIV medications. Clin Liver Dis 2007; 11: 615-39, vii-viii. (Review of hepatotoxicity of antiretroviral medications; ALT elevations occur in 2-18% of patients, but often resolve spontaneously even without dose modification; classes of injury include hypersensitivity [nevirapine, efavirenz, abacavir], mitochondrial injury [stavudine, didanosine, zidovudine], flares of hepatitis B [lamivudine, emtricitabine, tenofovir], flares of hepatitis C [any potent regimen], idiosyncratic injury [ritonavir, nevirapine, efavirenz], cholestatic hepatitis [many agents]). 17723923
Rivero A, Mira JA, Pineda JA. Liver toxicity induced by non-nucleoside reverse transcriptase inhibitors. J Antimicrob Chemother 2007; 59: 342-6. (Review of liver toxicity of nevirapine and efavirenz, ALT elevations >5 times ULN reported in 1-8% of efavirenz compared to 4-16% of nevirapine recipients; no mention of delavirdine or rilpivirine). 17255142
Soriano V, Puoti M, Garcia-Gascó Rockstroh JK, Benhamou Y, Barreiro P, McGovern B. Antiretroviral drugs and liver injury. AIDS 2008; 22: 1-13. (Review of hepatotoxicity of antiretroviral drugs with recommendations on management, stopping therapy if symptoms arise, with overt jaundice [direct bilirubin], evidence of mitochondrial toxicity, ALT >10 times ULN, ALT at lower levels if newly marketed agent; important to rule out other causes; problematic agents include didanosine, stavudine and zidovudine; nevirapine and efavirenz, full dose ritonavir and tipranavir). 18090386
Hughes CA, Robinson L, Tseng A, MacArthur RD. New antiretroviral drugs: a review of the efficacy, safety, pharmacokinetics, and resistance profile of tipranavir, darunavir, etravirine, rilpivirine, maraviroc, and raltegravir. Expert Opin Pharmacother 2009; 10: 2445-66. (Review of new antiretroviral agents including rilpivirine states that grade 3 or 4 adverse events and laboratory abnormalities were similar between rilpivirine and efavirenz treated patients with no specific discussion of hepatotoxicity or ALT elevations). 19678794
Rilpivirine(Edurant).a new drug for HIV infection. Med Lett Drugs Ther 2011; 53 (1371): 67-8. (Concise review of the safety and efficacy of rilpivirine shortly after its approval in the US; common side effects include depression, insomnia, headache and rash; ALT elevations and hepatotoxicity are not mentioned). 21860365
Molina JM, Cahn P, Grinsztejn B, Lazzarin A, Mills A, Saag M, Supparatpinyo K, et al.; ECHO study group. Rilpivirine versus efavirenz with tenofovir and emtricitabine in treatment-naive adults infected with HIV-1 (ECHO): a phase 3 randomised double-blind active-controlled trial. Lancet 2011; 378 (9787): 238-46. (Controlled trial of rilpivirine vs efavirenz [combined with tenofovir and emtricitabine] in 690 treatment naï subjects with HIV infection analyzed after 48 weeks; ALT elevations above 5 times ULN occurred in 1% of rilpivirine vs 4% of efavirenz treated patients, no mention of clinically apparent liver injury). 21763936
Cohen CJ, Andrade-Villanueva J, Clotet B, Fourie J, Johnson MA, Ruxrungtham K, Wu H, et al.; THRIVE study group. Rilpivirine versus efavirenz with two background nucleoside or nucleotide reverse transcriptase inhibitors in treatment-naive adults infected with HIV-1 (THRIVE): a phase 3, randomised, non-inferiority trial. Lancet 2011; 378(9787): 229-37. (Controlled trial of 96 weeks of rilpivirine vs efavirenz [combined with two nucleoside analogues] in 680 subjects with HIV infection showed similar efficacy but fewer side effects with rilpivirine, discontinuations in 4% vs 7%, ALT elevations above 5 times ULN in 2% vs 3%, and no mention of clinically apparent liver injury). 21763935
Sharma M, Saravolatz LD. Rilpivirine: a new non-nucleoside reverse transcriptase inhibitor. J Antimicrob Chemother 2012 Oct 29. [Epub ahead of print] (Review of pharmacology, efficacy and safety of rilpivirine; no discussion of ALT elevations or hepatotoxicity). 23099850
Ahmed Y, Siddiqui W, Enoch CB, Albrecht H, Bookstaver PB. Rare case of rilpivirine-induced severe allergic hepatitis. J Antimicrob Chemother 2012 Oct 12. [Epub ahead of print] (28 year old man with HIV infection developed fever and fatigue within days of adding rilpivirine to his antiviral regimen [bilirubin 1.0 mg/dL, ALT 1516 U/L, Alk P 293 U/L], improving rapidly and liver tests being normal within 16 days of stopping; Case 1). 23065700
Patel N, Miller CD. New option for management of HIV-1 infection in treatment-naive patients: once-daily, fixed-dose combination of rilpivirine-emtricitabine-tenofovir. HIV AIDS (Auckl) 2012; 4: 61-71. (Review of safety and efficacy of rilpivirine and its fixed dose combination with tenofovir and emtricitabine as therapy of HIV infection; no discussion of ALT elevations or hepatotoxicity). 22570576
James C, Preininger L, Sweet M. Rilpivirine: a second-generation nonnucleoside reverse transcriptase inhibitor. Am J Health Syst Pharm 2012; 69: 857-61. (Review of the pharmacology, efficacy and safety of rilpivirine in HIV infection; no discussion of ALT elevations or hepatotoxicity). 22555080
Nelson M, Amaya G, Clumeck N, Arns da Cunha C, Jayaweera D, Junod P, Li T, Tebas P, et al.; ECHO and THRIVE Study Groups. Efficacy and safety of rilpivirine in treatment-naive, HIV-1-infected patients with hepatitis B virus/hepatitis C virus coinfection enrolled in the Phase III randomized, double-blind ECHO and THRIVE trials. J Antimicrob Chemother 201; 67: 2020-8. (Pooled analysis of 2 controlled trials of rilpivirine vs efavirenz for their safety and efficacy in subgrounds of patients with HIV/HBV [n=55] and HIV/HCV [n=57] coinfection; ALT elevations occurred in 11.1% on rilpivirine vs 10.6% on efavirenz in coinfected compared to 1.1% vs 1.9% in noncoinfected patients; there was 1 case of acute hepatitis in each group; discontinuations for hepatic adverse events were reported in 3 rilpivirine vs 9 efavirenz treated subjects). 22532465
Cohen CJ, Molina JM, Cahn P, Clotet B, Fourie J, Grinsztejn B, Wu H, et al.; ECHO Study Group; THRIVE Study Group. Efficacy and safety of rilpivirine (TMC278) versus efavirenz at 48 weeks in treatment-naï HIV-1-infected patients: pooled results from the phase 3 double-blind randomized ECHO and THRIVE Trials. J Acquir Immune Defic Syndr 2012; 60: 33-42. (Pooled analysis of 3 controlled trials of 48 weeks of rilpivirine [n=686] vs efavirenz [n=682] in HIV infection; efficacy was similar, but adverse events were fewer with rilpivirine, including lower rates of grade 2 ALT elevations [5% vs 8%]; no mention of clinically apparent liver injury). 22343174
Wilkin A, Pozniak AL, Morales-Ramirez J, Lupo SH, Santoscoy M, Grinsztejn B, Ruxrungtham K, et al.; TMC278-C204 Study Group. Long-term efficacy, safety, and tolerability of rilpivirine (RPV, TMC278) in HIV type 1-infected antiretroviral-naive patients: week 192 results from a phase IIb randomized trial. AIDS Res Hum Retroviruses 2012; 28: 437-46. (Analysis of efficacy and safety of open label, long term, extended therapy [192 weeks] with rilpivirine [n=279] vs efavirenz [n=89] with 2 nucleoside analogues; ALT elevations were reported in 6% of both groups, mostly occurring during the first 48 weeks of therapy; no mention of clinically apparent liver injury). 21902621
Casado JL. Liver toxicity in HIV-infected patients receiving novel second-generation nonnucleoside reverse transcriptase inhibitors etravirine and rilpivirine. AIDS Rev 2013; 15: 139-45. (Review of the liver toxicity of etravirine and rilpivirine compared to efavirenz and other NNRTIs concludes that both new agents have low rates of liver toxicity and can be used safely in patients with HCV coinfection). 24002197
Surgers L, Lacombe K. Hepatoxicity of new antiretrovirals: a systematic review. Clin Res Hepatol Gastroenterol 2013; 37: 126-33. (Systematic review of rates of liver injury reported in clinical trials of recently approved antiretroviral agents including rilpivirine). 23522569
Chalasani N, Bonkovsky HL, Fontana R, Lee W, Stolz A, Talwalkar J, Reddy KR, et al.; United States Drug Induced Liver Injury Network. Features and outcomes of 899 patients with drug-induced liver injury: The DILIN Prospective Study. Gastroenterology 2015; 148: 1340-1352.e7. (Among 899 cases of drug induced liver injury enrolled in a US prospective study between 2004 and 2013, 12 were attributed to antiretroviral agent, but none to rilpivirine). 25754159
Gianotti N, Poli A, Nozza S, Spagnuolo V, Tambussi G, Bossolasco S, Cinque P, et al. Efficacy and safety in clinical practice of a rilpivirine, tenofovir and emtricitabine single-tablet regimen in virologically suppressed HIV-positive patients on stable antiretroviral therapy. J Int AIDS Soc 2015; 18: 20037. (Among 307 patients with HIV infection on antiviral regimens who were switched to the single tablet regimen of rilpivirine, tenofovir and emtricitabine [Complera], virologic failure occurred in only 3 patients [1%] and there were only minor changes in median serum ALT, Alk P and bilirubin levels; no mention of clinically apparent liver injury). 26232000
Neukam K, Espinosa N, Collado A, Delgado-Fernández M, Jiménez-Aguilar P, Rivero-Juárez A, Hontañón-Antoñana V, et al.; hEPAtic Study Group. Hepatic safety of rilpivirine/emtricitabine/tenofovir disoproxil fumarate fixed-dose single-tablet regimen in HIV-infected patients with active hepatitis C virus infection: the hEPAtic Study. PLoS One 2016; 11: e0155842. (Retrospective analysis of 173 patients coinfected with HIV and HCV who started combination therapy with rilpivirine, emtricitabine and tenofovir [RET] and 346 controls found incidence of serum enzyme elevations above 5 times ULN to be only 1.2% with RET and 3.2% in controls on various regimens, while liver related deaths occurred in 0.6% vs 0.2% in controls). 27195797

## OTHER REFERENCE LINKS

1. Recent References on Rilpivirine: from PubMed.gov (https://www.ncbi.nlm.nih.gov/sites/entrez?cmd=search&db=pubmed&pubmedfilters=true&term=(Rilpivirine/AE)+AND+Human%5BMH%5D+AND+(drug+induced+liver+injury+OR+jaundice/CI+OR+bile+duct+diseases/CI+OR+liver/DE+OR+liver+diseases/CI)+AND+(%221900/1/1%22%5BEDat%5D%3A%222999/12/31%22%5BEDat%5D))
2. Trials on Rilpivirine: from ClinicalTrials.gov (https://clinicaltrials.gov/ct2/results?term=Rilpivirine)